# Artesunate

## OVERVIEW

### Introduction

Artesunate for injection is an antimalarial drug used as the initial treatment of severe malaria in both adults and children. Typically, infusions of artesunate are continued for 2 to 7 days until the patient can tolerate oral antimalarial therapy. Artesunate therapy is associated with mild-to-moderate serum aminotransferase elevations during therapy but has not been linked instances of clinically apparent liver injury.

### Background

Artesunate (ar tes’ sun ate) is an intravenously administered antimalarial agent that is used in the initiation of treatment for severe malaria and is continued until the patient can tolerate an appropriate effective oral antimalarial therapy. Artesunate is rapidly metabolized to its active ingredient, dihydroartemisinin (DHA), which induces oxidative stress and inhibits protein and nucleic acid synthesis in plasmodium species that cause malaria. Artesunate has been shown to decrease in-hospital mortality of severe malaria by at least 40% and was approved for this indication in the United States in 2020. Artesunate is available in powdered form in single use vials of 110 mg for reconstitution under the name Artesunate. The recommended dose regimen is 2.4 mg per kg body weight intravenously at 0, 12, and 24 hours followed by once daily until oral therapy can be initiated. Artesunate treatment should be followed by an appropriate oral regimen for malaria. In prelicensure trials, serious adverse events included acute renal failure (9%), hemolysis (7%), and jaundice (2.3%). Artesunate can also cause hypersensitivity reactions including rash, urticaria, anaphylaxis, and Stevens Johnson syndrome. Artesunate given intravenously caused fetal harm in rats, but it is recommended to be given in pregnant women because of the greater harm to mother and child of inadequately treated, severe malaria.

### Hepatotoxicity

In an open label study of severe malaria in 104 patients in the United States, elevations in ALT occurred in 27% of subjects, AST in 49%, and bilirubin in 17%. These abnormalities, however, were attributable to the hemolysis and liver involvement that are common in patients with acute, severe malaria. None of the elevations were attributed to drug induced liver injury. Since licensure of artesunate for injection and its more widescale clinical use in the United States, there have been no reports of acute liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of liver test abnormalities during artesunate therapy of malaria are not known and are more likely due to the underlying severe infection rather than the infused drug. Artesunate can cause hypersensitivity reactions including Stevens Johnson syndrome, and liver injury might be a part of the immunoallergic reaction.

### Outcome and Management

The product label for artesunate does not recommend monitoring of routine liver tests during therapy and the duration of treatment is usually brief, so that there is generally no chance to respond to occurrence of liver abnormalities and jaundice, which are frequent manifestations of acute severe malaria and resolve rapidly with successful therapy.

Drug Class: Antimalarial Agents

Related Artemisinin Derivative: Artemisinin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Artesunate – Artesunate®

DRUG CLASS

Antimalarial Agents

COMPLETE LABELING (https://www.accessdata.fda.gov/drugsatfda_docs/label/2020/213036s000lbl.pdf)

Product labeling at the Food and Drug Administration

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Artesunate | 88495-63-0 | C19-H28-O8

## SELECTED ANNOTATED BIBLIOGRAPHY

References updated: 05 August 2024

FDA. Clinical Review. 2020.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213036Orig1s000MultidisciplineR.pdf (FDA Summary of the data the safety and efficacy of artesunate for injection, submitted in support of the application for approval as therapy of severe malaria, mentions that in studies of 102 patients with severe malaria treated in the US, ALT elevations arose in 2.9%, AST in 26%, and bilirubin in 13.7%, but AST and bilirubin might have been raised because of hemolytic anemia; nevertheless, one subject died of acute liver failure, no details provided).
CDC. Malaria. https://www.cdc.gov/malaria/hcp/clinical-guidance/index.html (CDC website with information on the prevalence, clinical features, diagnosis, and management of malaria also has information on how to obtain intravenous artesunate for treatment of acute severe malaria).
Hess KM, Goad JA, Arguin PM. Intravenous artesunate for the treatment of severe malaria. Ann Pharmacother. 2010;44:1250-8. (Systematic review of the efficacy and safety of intravenous artesunate as therapy of severe malaria states that “it is considered to be well tolerated”; no mention of ALT elevations or hepatoxicity). 20551300
Sinclair D, Donegan S, Isba R, Lalloo DG. Artesunate versus quinine for treating severe malaria. Cochrane Database Syst Rev. 2012;2012:CD005967. (Systematic review and meta-analysis of 8 controlled trials of artesunate vs quinine for severe malaria found that artesunate led to lower rates of mortality in both adults [n=1664: 14.7% vs 24%] and children [n=5765: 8% vs 11%] and that “with exception of hypoglycemia and tinnitus, all adverse events could be attributed to malaria”). 22696354
Twomey PS, Smith BL, McDermott C, Novitt-Moreno A, McCarthy W, Kachur SP, Arguin PM. Intravenous artesunate for the treatment of severe and complicated malaria in the United States: clinical use under an investigational new drug protocol. Ann Intern Med. 2015;163:498-506. (Among 102 adults with acute severe and complicated malaria treated in the US with intravenous artesunate, most patients began to improve within 3 days and the mortality rate was 7%, all patients dying having presented with moderate-to-severe liver injury; the overall adverse event rate was 92% and the major adverse events were anemia [65%], elevations in AST [49%], ALT [27%], and bilirubin [17%], and acute renal failure [10%], the serum enzyme elevations being most likely from hemolytic anemia and the underlying malaria infection). 26301474

## OTHER REFERENCE LINKS

1. Recent References on Artesunate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Artesunate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Artesunate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Artesunate)